# Sickle Cell Disease Agents

## OVERVIEW

### Introduction

Sickle cell disease is caused by an inherited mutation in the β globin gene that creates hemoglobin S, an abnormal form of hemoglobin which is prone to polymerization when exposed to low oxygen tension which results in sickling of red blood cells, hemolytic anemia, vascular occlusion of small vessels, ischemic tissue and organ injury and recurrent painful crises. Drugs for sickle cell disease include agents that increase fetal hemoglobin, which has a higher affinity for oxygen and can decrease sickling and agents that act downstream from sickling in preventing the microvascular occlusions due to the sickled red cells by inhibition of hemoglobin S polymerase, decreasing oxidative stress, and lessening of sickle cell adhesion to endothelial cells.

### Background

Sickle cell disease is caused by an inherited mutation in the β globin gene that creates hemoglobin S, an abnormal form of hemoglobin which is prone to polymerization with deoxygenation resulting in sickling of red blood cells, hemolytic anemia, vascular occlusion of small vessels, ischemic tissue and organ injury and recurrent painful crises. Sickle cell disease affects at least 100,000 Americans and is most common in persons of African descent. Long term complications include disability due to recurrent painful crises, acute chest syndrome, pulmonary hypertension, stroke and cerebral infracts, end-organ damage and early mortality. Most of the complications of sickle cell disease are due to the vaso-occlusive crises caused the aggregates of sickled red cells, platelets, leukocytes adhering to endothelial cells and causing vascular stasis and ischemic injury to tissues. The recurrent vaso-occlusive crises can cause cerebral vascular stokes, pulmonary hypertension, renal and hepatic dysfunction, splenic infarcts and injury to bone and muscle. Drugs for sickle cell disease target the prevention of sickle cell formation, but also the subsequent vaso-occlusive crises which is the result of the sickled cells forming aggregates with platelets and leukocytes that adhere to microvascular endothelial cells causing obstruction and local ischemic damage. A non-pharmacologic approach to management of sickle cell anemia is chronic transfusions to raise the hemoglobin level and provide normal hemoglobin and its oxygen carrying ability. Medications specifically approved for use in sickle cell disease include hydroxyurea, L-glutamine, voxelotor and crizanlizumab all of which act on a different target in the pathway of vaso-occlusive crises.

Hydroxyurea is an antimetabolite used in cancer chemotherapy, particularly in chronic myelogenous leukemic and head and neck cancers. In addition, chronic therapy with hydroxyurea has a beneficial effect in sickle cell disease by increasing fetal hemoglobin synthesis (hemoglobin F) which provides a proportion of normal oxygen carrying hemoglobin. Chronic therapy with hydroxyurea can decrease sickling and increase hemoglobin levels, with a decrease in vaso-occlusive crises and improvement in general well-being in individuals with sickle cell disease. Hydroxyurea was approved for use in sickle cell disease in 1998 and is considered a first line therapy in management of this disease.

L-glutamine is an amino acid that serves as an important precursor of key antioxidant compounds that act to decrease oxidative stress which is common in sickled red cells. The tissue levels of endogenous antioxidants are often deficient in sickle cell disease and can be increased by L-glutamine intake. L-glutamine appears to act in decreasing painful crises in sickle cell disease by increasing levels of nicotinamide adenine dinucleotide (NAD) and glutathione, essential molecules in intracellular oxidative-reductive balance and metabolism. L-glutamine was approved for use in sickle cell disease in 2017 but has not had widespread use.

Voxelotor is a small molecular inhibitor of hemoglobin S polymerization. Voxelotor binds to and stabilizes the R oxygen high-affinity conformation of HbS, thus decreasing the concentration of the T conformation that is prone to polymerization. While voxelotor has been shown to raise hemoglobin levels and decrease reticulocytes in patients with sickle cell disease, it has not been shown to decrease vaso-occlusive crises or prevent organ damage. Voxelotor was approved for use in sickle cell disease in 2019 but has not had widespread use.

Crizanlizumab is a humanized IgG2 monoclonal antibody to P-selectin, an important adhesion molecule that is expressed on activated platelets and leukocytes and mediates adhesion of sickle cell aggregates to endothelial cells. Crizanlizumab has been shown to decrease vaso-occlusive crises, but does not increase hemoglobin levels or reduce hemolysis in sickle cell disease.

### Hepatotoxicity

None of the four approved drugs for sickle cell disease have been associated with serious hepatotoxicity. Low rates of transient, asymptomatic, mild-to-moderate serum enzyme elevations can occur with hydroxyurea and voxelotor, and rare instances of clinically apparent liver injury with jaundice have been reported with hydroxyurea. Diagnosis of drug induced liver injury is challenging in patients with sickle cell disease because they frequently have mild jaundice due to the chronic hemolysis. In addition, patients with sickle cell disease often have serum enzyme elevations due to chronic liver injury, the result of complications of the disease and its treatment, such as chronic viral hepatitis and iron overload from frequent blood transfusions, gallstone disease from chronic hemolysis, congestive liver injury from pulmonary hypertension, ischemic hepatopathy from microvascular crises in the liver, and nodular regenerative hyperplasia probably from chronic microvascular injury. Thus, jaundice and other evidence of liver disease can occur independent of the use of medications for sickle cell disease and the differential diagnosis can be challenging.

Full discussion of the potential hepatotoxicity of drugs for sickle cell disease and references to their safety are given in the following individual chapters in LiverTox.

Crizanlizumab

Hydroxyurea

L-Glutamine

Voxelotor

## SELECTED ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2021

Brawley OW, Cornelius LJ, Edwards LR, Gamble VN, Green BL, Inturrisi C, James AH, et al. (2008). National Institutes of Health Consensus Development Conference statement: hydroxyurea treatment for sickle cell disease. Ann Intern Med. (Consensus statement on use of hydroxyurea in patients with sickle cell disease).
Platt OS. (2008). Hydroxyurea for the treatment of sickle cell anemia. N Engl J Med. (Review of the mechanism of action, efficacy and safety of hydroxyurea therapy of sickle cell disease mentions potential of embryotoxicity, myelotoxicity and cancer, but does not discuss ALT elevations or hepatotoxicity).
Rees DC, Williams TN, Gladwin MT. (2010). Sickle-cell disease. Lancet. (Review of the pathogenesis, clinical features, natural history, complications, management and therapy of sickle cell disease).
Steinberg MH, McCarthy WF, Castro O, Ballas SK, Armstrong FD, Smith W, Ataga K, et al., Investigators of the Multicenter Study of Hydroxyurea in Sickle Cell Anemia and MSH Patients' Follow-Up. (2010). The risks and benefits of long-term use of hydroxyurea in sickle cell anemia: A 17.5 year follow-up. Am J Hematol. (Long term follow up of patients with sickle cell disease in a clinical trial of hydroxyurea found evidence of improved survival without apparent severe adverse events; liver disease occurred in 6% of patients and was less in hydroxyurea treated subjects and persons who survived more than 10 years).
Koh C, Turner T, Zhao X, Minniti CP, Feld JJ, Simpson J, Demino M, et al. (2013). Liver stiffness increases acutely during sickle cell vaso-occlusive crisis. Am J Hematol. (Among 23 patients with sickle cell disease evaluated before and during an acute vaso-occlusive crisis, serum liver enzyme elevations did not change appreciably but hepatic stiffness increased [measured by ultrasound transient elastography] as did serum total and indirect bilirubin and reticulocyte counts, while serum albumin and hemoglobin decreased).
Feld JJ, Kato GJ, Koh C, Shields T, Hildesheim M, Kleiner DE, Taylor JG, et al. (2015). Liver injury is associated with mortality in sickle cell disease. Aliment Pharmacol Ther. (Among 247 patients with sickle cell disease, liver disease was common, elevations in ALT were present in 16% and alkaline phosphatase in 33%; factors associated with mortality during follow up were iron indices [serum ferritin, transferrin, and iron] and liver abnormalities [direct bilirubin, albumin and alkaline phosphatase levels]; liver biopsy done in 40 patients revealed nodular regenerative hyperplasia in 36% and portal venopathy in 23%).
(2018). L-glutamine (Endari) for sickle cell disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of L-glutamine for sickle cell disease describes its adverse effects to include constipation, nausea, headache, abdominal pain, pain in back and extremities, cough and chest pain, but does not mention ALT elevations or hepatotoxicity).
(2020). Two drugs for sickle cell disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of crizanlizumab and voxelotor shortly after their approval for use in sickle cell disease in the US; no mention of ALT elevations or hepatotoxicity).
Osunkwo I, Manwani D, Kanter J. (2020). Current and novel therapies for the prevention of vaso-occlusive crisis in sickle cell disease. Ther Adv Hematol. (Extensive review of the pathogenesis of sickle cell vaso-occlusive crises and potential therapeutic avenues for their prevention and treatment including induction of hemoglobin F [hydroxyurea], decreasing oxidative stress [L-glutamine], decreasing red cell adhesion [crizanlizumab], and inhibiting hemoglobin polymerization [voxelotor]).
Tisdale JF, Thein SL, Eaton WA. (2020). Treating sickle cell anemia. Science. (Review of mechanism of action and efficacy of current [hydroxyurea and voxelotor] and the promise of future therapies of sickle cell anemia [including bone marrow transplantation and gene therapy]).
Darbari DS, Sheehan VA, Ballas SK. (2020). The vaso-occlusive pain crisis in sickle cell disease: definition, pathophysiology, and management. Eur J Haematol. (Extensive review of the pathogenesis of vaso-occlusive crisis in patients with sickle cell disease and therapies that target different steps in the process including inflammation, adhesion, oxidative stress, and oxygen affinity and stability of hemoglobin; discusses efficacy of L-glutamine, voxelotor and crizanlizumab, mentioning that all three are well tolerated; no mention or discussion of hepatotoxicity).
Ali MA, Ahmad A, Chaudry H, Aiman W, Aamir S, Anwar MY, Khan A. (2020). Efficacy and safety of recently approved drugs for sickle cell disease: a review of clinical trials. Exp Hematol. (Review of randomized controlled trials of 3 recently approved drugs for sickle cell disease focusing upon L-glutamine, voxelotor, and crizanlizumab states that all three are “well tolerated without any alarming adverse effects”; no mention of ALT elevations or hepatotoxicity).
Pace BS, Starlard-Davenport A, Kutlar A. (2021). Sickle cell disease: progress towards combination drug therapy. Br J Haematol. (Review of the pathophysiology of sickle cell disease and vaso-occlusive crises and mechanism of action of drugs used to treat sickle cell disease and drugs currently under investigation for efficacy in decreasing the microvascular occlusive crises that mediate much of the morbidity and mortality of this disease).